# Anastrozole

## OVERVIEW

### Introduction

Anastrozole is a nonsteroidal inhibitor of aromatase which effectively blocks estrogen synthesis in postmenopausal women and is used as therapy of estrogen receptor positive breast cancer. Anastrozole has been associated with a low rate of serum enzyme elevations during therapy and rare instances of clinically apparent liver injury.

### Background

Anastrozole (an as' troe zole) is a nonsteroidal inhibitor of aromatase, the enzyme responsible for the conversion of testosterone to estrone (E1) and of androstenedione to estradiol (E2). Highest levels of aromatase are found in the ovary and placenta, which are the major sources of estrogen in premenopausal women. However, aromatase is also found in other tissues, such as liver, kidney, adrenals, brain, muscle and subcutaneous fat where it is also active in producing estrogens, although at low levels. These tissues are the major source of estrogen in postmenopausal women. Inhibitors of aromatase were developed to block the synthesis of estrogen in the peripheral tissues and, thus, as antiestrogen therapy of estrogen receptor positive breast cancer in postmenopausal women. The aromatase inhibitors in current use include letrozole, exemestane and anastrozole. Anastrozole is a nonsteroidal, specific aromatase inhibitor which has little or no effect on adrenal glucocorticoid or mineralocorticoid synthesis. Anastrozole was approved for use in postmenopausal women with breast cancer in the United States in 1995. Anastrozole is available in 1 mg tablets in generic forms and under the brand name Arimidex. Its current indications are as adjuvant therapy in postmenopausal women with hormone responsive breast cancer, as first line therapy of locally invasive or metastatic estrogen receptor positive breast cancer in postmenopausal women, and as adjuvant therapy in postmenopausal women with advanced breast cancer not responsive to tamoxifen. It is typically given in single oral doses of 1 mg daily for up to five years. Common side effects include hot flashes, night sweats, fatigue, dizziness, headache, somnolence, abdominal discomfort, nausea, arthralgias, weight gain and rash. Uncommon, but potentially severe side effects include decrease in bone mineral density, increase in serum cholesterol and increased rate of cardiovascular events.

### Hepatotoxicity

Serum enzymes are reported to be elevated in 2% to 4% of women treated with anastrozole, but these elevations are usually mild, asymptomatic and self-limited, rarely requiring dose modification. There have been rare instances of clinically apparent liver injury associated with anastrozole therapy, typically arising within 1 to 4 months of starting treatment and having variable presentations but generally with a hepatocellular or mixed serum enzyme pattern (Case 1). Too few instances have been described in the literature to provide specific characteristics or clinical phenotype. Immunoallergic features (fever, rash, eosinophilia) were not mentioned in published cases, but low levels of autoantibodies were sometimes found. Recovery is usually rapid once anastrozole is stopped. There have been no cases of acute liver failure, chronic hepatitis or vanishing bile duct syndrome attributed to anastrozole use. Unlike tamoxifen, anastrozole has not been associated with development of fatty liver disease, although some degree of steatosis and steatohepatitis have been mentioned in descriptions of liver biopsies from acute cases. According to the product label, anastrozole has been linked to cases of hypersensitivity reactions and Stevens-Johnson syndrome as well as cases of hepatitis with jaundice.

Likelihood score: C (probable cause of clinically apparent liver injury).

### Mechanism of Injury

The liver injury attributed to anastrozole use is probably due to a toxic or immunoallergic intermediate of its metabolism. Anastrozole is metabolized in the liver by the cytochrome P450 system and is a strong inhibitor of CYP 2A6 and to a lesser extent CYP 2C19.

### Outcome and Management

Liver injury attributed to anastrozole is usually mild and self-limited, typically a transient, asymptomatic elevation in serum enzymes. Cases of severe hepatitis have been reported in women on anastrozole, but acute liver failure has not. There is little evidence for cross sensitivity to liver injury between anastrozole and tamoxifen or even among the various aromatase inhibitors (which have distinctly different chemical structures).

References to the safety and hepatotoxicity of anastrozole are given below as well as together with those on exemestane and letrozole after the Overview section on Aromatase Inhibitors.

Drug Class: Antineoplastic Agents, Antiestrogens, Aromatase Inhibitors

Other Drugs in the Subclass, Aromatase Inhibitors: Exemestane, Letrozole

## CASE REPORT

### Case 1. Clinically apparent, acute liver injury due to anastrozole.

[Modified from: Zapata E, Zubiaurre L, Bujanda L, Piérola A. Anastrozole-induced hepatotoxicity. Eur J Gastroenterol Hepatol 2006; 18: 1233-4. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/17033446)]

An 89 year old postmenopausal woman with estrogen receptor positive breast cancer developed malaise, nausea and vomiting 2 months after starting anastrozole. She had no previous history of liver disease, did not drink alcohol and had no risk factors for viral hepatitis. Before starting anastrozole, serum enzyme levels were reportedly normal. Her other medical conditions included a previous history of bone tuberculosis which was inactive, high blood pressure for which she took diuretics (hydrochlorothiazide), arthritis, vertigo, and urinary incontinence for which she took tolterodine (an anticholinergic). Physical examination revealed jaundice, but no evidence of chronic liver disease or cirrhosis. Laboratory testing showed total bilirubin 3.6 mg/dL (direct 1.5 mg/dL), ALT 410 U/L, AST 255 U/L, alkaline phosphatase 231 U/L, and GGT 364 U/L. Tests for hepatitis A, B and C were negative as were antinuclear and smooth muscle antibody. Ultrasound and CT of the abdomen showed a normal appearing liver with no evidence of biliary obstruction or intrahepatic masses. Anastrozole was stopped and she began to improve. Two weeks later, laboratory tests had returned to normal and she was without symptoms.

#### Key Points

Medication: | Anastrozole
Pattern: | Hepatocellular (R=6.5)
Severity: | 3+ (jaundice and hospitalization)
Latency: | 2 months
Recovery: | 2 weeks
Other medications: | Hydrochlorothiazide, tolterodine

#### Laboratory Values

Time After Starting | Time After Stopping | ALT (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Other
Pre | Pre | Normal | Normal | Normal | Breast cancer diagnosis
8 weeks | 0 | 410 | 213 | 3.6 | Anastrozole stopped
| 3 days | 100 | 133 | 0.8 | Imaging normal
10 weeks | 2 weeks | 18 | 94 | 0.6 | Asymptomatic
Normal Values | | <31 | <104 | <1.2

#### Comment

The clinical presentation of a mild hepatocellular jaundice arising 2 months after starting anastrozole, the exclusion of other common causes of jaundice, and the prompt improvement on stopping the medication all point to anastrozole induced liver injury.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Anastrozole – Generic, Arimidex®

DRUG CLASS

Antineoplastic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Anastrozole)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Anastrozole | 120511-73-1 | C17-H19-N5 | Anastrozole Chemical Structure

## ANNOTATED BIBLIOGRAPHY

References updated: 25 July 2017

Zimmerman HJ. Unconventional drugs. Miscellaneous drugs and diagnostic chemicals. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 731-4. (Expert review of hepatotoxicity published in 1999, before the availability of anastrozole and the aromatase inhibitors).
Chitturi S, Farrell GC. Estrogen receptor antagonists. Adverse effects of hormones and hormone antagonists on the liver. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 610-2. (Review of hepatotoxicity of tamoxifen mentions that nonalcoholic fatty liver disease is the most common form of liver injury due to tamoxifen which has also been reported to cause peliosis hepatis, acute hepatitis, submassive hepatic necrosis and liver cancer).
Moy B, Lee RJ, Smith M. Anti-estrogen therapy. Natural products in cancer chemotherapy. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 1756-9. (Textbook of pharmacology and therapeutics).
Carlini P, Papaldo P, Fabi A, Felici A, Ruggeri EM, Milella M, Ciccarese M, et al. Liver toxicity after treatment with gefitinib and anastrozole: drug-drug interactions through cytochrome p450? J Clin Oncol 2006; 24: e60-1. (63 year old woman developed ALT elevations [peak 213 U/L] while on gefitinib and anastrozole, which decreased when gefitinib was stopped and increased again when it was restarted). 17158530
Zapata E, Zubiaurre L, Bujanda L, Pierola A. Anastrozole-induced hepatotoxicity. Eur J Gastroenterol Hepatol 2006; 18: 1233-4. (89 year old woman with breast cancer developed fatigue 2 months after starting anastrozole [bilirubin 1.6 mg/dL, ALT 410 U/L, Alk P 231 U/L], resolving within 2 weeks of stopping). 17033446
de la Cruz L, Romero-Vazquez J, Jimenez-Saenz M, Padron JR, Herrerias-Gutierrez JM. Severe acute hepatitis in a patient treated with anastrozole. Lancet 2007; 369 (9555): 23-4. (58 year old woman with breast cancer developed jaundice 3 weeks after starting anastrozole [bilirubin 10.9 mg/dL, ALT 2012 U/L, Alk P 4 times ULN], biopsy showing centrolobular necrosis, liver injury resolving rapidly upon stopping, but patient died of complications of emergency ulcer surgery one month later). 17208628
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J; Drug Induced Liver Injury Network (DILIN). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology 2008; 135: 1924-34. (Among 300 cases of drug induced liver disease in the US collected between 2004 and 2008, none were attributed to antiestrogens such as exemestane, letrozole, anastrozole or tamoxifen). 18955056
Reuben A, Koch DG, Lee WM; Acute Liver Failure Study Group. Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology 2010; 52: 2065-76. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury, but none were attributed to anastrozole or other antiestrogens). 20949552
Dowsett M, Cuzick J, Ingle J, Coates A, Forbes J, Bliss J, Buyse M, et al. Meta-analysis of breast cancer outcomes in adjuvant trials of aromatase inhibitors versus tamoxifen. J Clin Oncol 2010; 28: 509-18. (Meta analysis of trials comparing aromatase inhibitors to tamoxifen as adjuvant therapy of breast cancer in postmenopausal women; no discussion of hepatotoxicity or rates of ALT elevations). 19949017
Aromatase inhibitors for adjuvant treatment of postmenopausal breast cancer. Med Lett Drugs Ther 2011 13; 53 (1366):47-8. (Concise review of the aromatase inhibitors and their role in therapy of breast cancer in postmenopausal women; no discussion of adverse events). 21659970
Inno A, Basso M, Vecchio FM, Marsico VA, Cerchiaro E, D'Argento E, Bagalà, Barone C. Anastrozole-related acute hepatitis with autoimmune features: a case report. BMC Gastroenterol 2011; 11: 32. (70 year old woman developed fatigue and jaundice 4 months after starting anastrozole [bilirubin 3.5 mg/dL, ALT 1344 U/L, Alk P 640 U/L, ANA 1:80], resolving within 1 month of stopping and not recurring on tamoxifen). 21453541
Tomao F, Spinelli G, Vici P, Pisanelli GC, Cascialli G, Frati L, Panici PB, Tomao S. Current role and safety profile of aromatase inhibitors in early breast cancer. Expert Rev Anticancer Ther 2011; 11: 1253-63. (Review of efficacy and safety of aromatase inhibitors in early breast cancer; no discussion of hepatotoxicity or ALT elevations). 21916579
Goss PE, Ingle JN, Pritchard KI, Ellis MJ, Sledge GW, Budd GT, Rabaglio M, et al. Exemestane versus anastrozole in postmenopausal women with early breast cancer: NCIC CTG MA.27--a randomized controlled phase III trial. J Clin Oncol 2013; 31: 1398-404. (Among 7576 women with early breast cancer randomized to anastrozole or exemestane for 5 years, event-free survival was the same while mild bilirubin and ALT elevations were more common with exemestane [1.6% and 1.4%] than anastrozole [0.6% and 0.6%]; no mention of instances of clinically apparent liver injury). 23358971
Islam MS, Wright G, Tanner P, Lucas R. A case of anastrazole-related drug-induced autoimmune hepatitis. Clin J Gastroenterol 2014; 7: 414-7. (66 year old woman with breast cancer developed abnormal liver tests 6 months after starting anastrazole [bilirubin 2.5 mg/dL, ALT 621 U/L, Alk P 185 U/L, INR 1.4, ANA 1:160] which resolved 3 months after stopping anastrazole, but similar abnormalities arose a year later not on anticancer therapy [bilirubin 2.3 mg/dL, ALT 970 U.L, ANA 1:800] and responded to corticosteroid therapy). 26184021
Lin Y, Liu J, Zhang X, Li L, Hu R, Liu J, Deng Y, et al. A prospective, randomized study on hepatotoxicity of anastrozole compared with tamoxifen in women with breast cancer. Cancer Sci 2014; 105: 1182-8. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/24975596) (Among 353 postmenopausal women with breast cancer followed for 3 years, fatty liver developed in 41% on tamoxifen vs 15% on anastrozole, although rates of ALT elevations were similar in the two groups [any elevations, 16% vs 20%; more than 5 times ULN, <1% in both]).
Lacey R, Evans A. An unusual cause of jaundice in a patient with breast cancer. BMJ Case Rep 2014; 2014. (48 year old woman developed jaundice 2 months after starting anastrozole for metastatic breast cancer [bilirubin 33.2 mg/dL, ALT 98 U/L, Alk P 385 U/L, INR 1.9], liver biopsy showing "steatohepatitis" with resolution within 3-6 months of stopping). 25540208
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: the DILIN prospective study. Gastroenterology 2015; 148: 1340-52. (Among 899 cases of drug induced liver injury seen over a ten year period at 8 US medical centers, 7 were attributed to antiestrogens used in cancer chemotherapy including 4 to tamoxifen, 2 exemestane and 1 letrozole, but none were attributed to anastrozole). 25754159
Klapko O, Ghoulam E, Jakate S, Eswaran S, Usha L. Anastrozole-induced autoimmune hepatitis: a rare complication of breast cancer therapy. Anticancer Res 2017; 37: 4173-6. (71 year old woman with breast cancer developed abnormal liver tests 9 months after starting anastrazole [bilirubin 0.9 mg/dL, ALT 130 U/L, Alk P 95 U/L, ANA 1:1280] despite normal values before treatment, resolving once anastrozole was stopped, but also with prednisone and azathioprine therapy). 28739702
Hong N, Yoon HG, Seo DH, Park S, Kim SI, Sohn JH, Rhee Y. Different patterns in the risk of newly developed fatty liver and lipid changes with tamoxifen versus aromatase inhibitors in postmenopausal women with early breast cancer: A propensity score-matched cohort study. Eur J Cancer 2017; 82: 103-14. (In a retrospective cohort study of 328 Korean women with breast cancer receiving antiestrogen adjuvant therapy, fatty liver as detected by ultrasound arose in 13 per 100 patient years on tamoxifen versus 8 per 100 on aromatase inhibitors [anastrozole or letrozole], and those on tamoxifen were more likely to progress [42% vs 10%]). 28651157

## OTHER REFERENCE LINKS

1. Recent References on Anastrozole: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Anastrozole/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Anastrozole: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Anastrozole)